# Tesamorelin

## OVERVIEW

### Introduction

Tesamorelin is a synthetic growth hormone releasing hormone analogue used in the treatment of visceral adiposity in human immunodeficiency virus (HIV) infected patients with lipodystrophy. Tesamorelin is given subcutaneously and has major effects on glucose and lipid metabolism, but has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Tesamorelin (tes" a moe rel' in) is a synthetic 44 amino acid polypeptide analogue of growth hormone releasing hormone (GHRH). The N terminal portion of the molecule has been modified to improve its stability and pharmacokinetics in comparison to native GHRH. Tesamorelin activates GHRH receptors in the pituitary which leads to synthesis and release of growth hormone that acts on multiple cells of the body including hepatocytes where it stimulates production of insulin like growth factor-1 (IGF-1). IGF-1 mediates many of the effects of growth hormone, which in the liver include growth, inhibition of programmed cell death, glucose update and lipolysis. Serum IGF-1 levels tend to be low in patients with obesity, diabetes and particularly in those with lipodystrophy. Tesamorelin was evaluated and found to be effective in decreasing visceral adiposity in patients with lipodystrophy associated with antiretroviral therapy of human immunodeficiency virus (HIV) infection. Tesamorelin was approved for use in the United States as therapy to reduce excess abdominal fat in HIV-infected patients with antiviral therapy-related lipodystrophy in 2010. Tesamorelin is also being evaluated as therapy of insulin resistance, obesity and nonalcoholic fatty liver. Tesamorelin is available in solution in vials of 1 mg/mL under the brand name Egrifta. The recommended dose is 2 mg daily given by subcutaneous injection. Side effects are not common but can include injection site reactions, itching, arthralgia, myalgia and peripheral edema. Tesamorelin raises IGF-1 levels and monitoring for elevations during therapy is recommended. Potential, rare adverse events include stimulation of malignant tumor growth, glucose intolerance, diabetes and hypersensitivity reactions.

### Hepatotoxicity

In clinical trials in patients with HIV-associated lipodystrophy, tesamorelin therapy was not associated with de novo elevations in serum enzymes and, in some studies, was associated with decreases in preexisting ALT elevations, possibly mediated by improvements in nonalcoholic fatty liver. Instances of clinically apparent liver injury attributable to tesamorelin use have not been reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Tesamorelin is a synthetic polypeptide that acts upon growth hormone producing cells in the pituitary and is generally metabolized locally by the receptor bearing cells. As a polypeptide, tesamorelin is unlikely to have direct cytotoxicity. Allergic responses to its administration have not caused hepatic or systemic hypersensitivity responses.

Drug Class: Hormonal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tesamorelin – Egrifta Depot®

DRUG CLASS

Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tesamorelin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tesamorelin | 901758-09-6 | C221-H366-N72-O67-S.(C2-H4-O2)x- | Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Abbreviations: VAT, visceral adipose tissue; IGF-1, insulin-like growth factor-1.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999 before the availability of recombinant human growth hormone releasing hormone).
Chitturi s, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 605-20. (Review of hepatotoxicity of hormonal agents; tesamorelin is not discussed).
Moy B, Lee RJ, Smith M. Gonadotrophin-releasing hormone agonists and antagonists. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1764. (Textbook of pharmacology and therapeutics).
Falutz J, Allas S, Kotler D, Thompson M, Koutkia P, Albu J, Trottier B, et al. A placebo-controlled, dose-ranging study of a growth hormone releasing factor in HIV-infected patients with abdominal fat accumulation. AIDS 2005; 19: 1279-87. (Among 61 patients with HIV infection and excess visceral adipose tissue [VAT] treated with tesamorelin [1 or 2 mg sc daily] or placebo for 12 weeks, change in VAT was greatest with the higher dose [-16%] vs lower dose [-4%] and placebo [-5%], while adverse event rates were similar and liver test results “did not differ between the groups”). 16052083
Falutz J, Allas S, Blot K, Potvin D, Kotler D, Somero M, Berger D, et al. Metabolic effects of a growth hormone-releasing factor in patients with HIV. N Engl J Med 2007; 357: 2359-70. (Among 412 patients with HIV infection and excess visceral adiposity treated with tesamorelin or placebo by sc injection once daily for 26 weeks, mean VAT decreased with tesamorelin [-15%] more than placebo [+5%], and adverse event rates were similar with no liver related serious adverse events and mean serum ALT levels decreasing in both groups [-4 vs -2 U/L]). 18057338
Falutz J, Allas S, Mamputu JC, Potvin D, Kotler D, Somero M, Berger D, et al. Long-term safety and effects of tesamorelin, a growth hormone-releasing factor analogue, in HIV patients with abdominal fat accumulation. AIDS 2008; 22: 1719-28. (In an extension study after a 26 week randomized controlled trial, 154 patients with HIV infection and excess visceral adiposity who were treated for up to 52 weeks with tesamorelin continued to have reductions in average VAT scores, and no new adverse events were identified). 18690162
Falutz J, Mamputu JC, Potvin D, Moyle G, Soulban G, Loughrey H, Marsolais C, et al. Effects of tesamorelin (TH9507), a growth hormone-releasing factor analog, in human immunodeficiency virus-infected patients with excess abdominal fat: a pooled analysis of two multicenter, double-blind placebo-controlled phase 3 trials with safety extension data. J Clin Endocrinol Metab 2010; 95: 4291-304. (In a pooled analysis of 816 HIV infected patients with excess visceral adiposity treated with tesamorelin or placebo for up to 52 weeks, adverse event rates were similar in the two groups, and no liver related adverse events were mentioned). 20554713
Falutz J, Potvin D, Mamputu JC, Assaad H, Zoltowska M, Michaud SE, Berger D, et al. Effects of tesamorelin, a growth hormone-releasing factor, in HIV-infected patients with abdominal fat accumulation: a randomized placebo-controlled trial with a safety extension. J Acquir Immune Defic Syndr 2010; 53: 311-22. (Among 404 HIV infected patients with excess abdominal adiposity treated with tesamorelin or placebo for 6 months and then switched to placebo or given tesamorelin for another 6 months, VAT decreased with tesamorelin compared to placebo, but this effect was lost when tesamorelin was stopped while adverse event rates were similar with either treatment; no mention of ALT elevations or hepatotoxicity). 20101189
Grunfeld C, Dritselis A, Kirkpatrick P. Tesamorelin. Nat Rev Drug Discov 2011; 10: 95-6. (News report on the FDA approval of tesamorelin for reduction in excess abdominal adiposity in HIV infected persons with lipodystrophy). 21283099
Makimura H, Feldpausch MN, Rope AM, Hemphill LC, Torriani M, Lee H, Grinspoon SK. Metabolic effects of a growth hormone-releasing factor in obese subjects with reduced growth hormone secretion: a randomized controlled trial. J Clin Endocrinol Metab 2012; 97: 4769-79. (Among 60 adults with excess abdominal adiposity treated in a randomized controlled trial for 12 months, VAT decreased by 8% with tesamorelin while it increased by 11% with placebo, and there were no differences in “liver transaminases” between the two groups). 23015655
Stanley TL, Falutz J, Marsolais C, Morin J, Soulban G, Mamputu JC, Assaad H, et al. Reduction in visceral adiposity is associated with an improved metabolic profile in HIV-infected patients receiving tesamorelin. Clin Infect Dis 2012; 54: 1642-51. (In retrospective analyses of two large controlled trials of tesamorelin in HIV infected patients with excess VAT, those who responded to treatment with reduction in VAT also had greater reductions in triglyceride levels and measures of glucose homeostasis). 22495074
Spooner LM, Olin JL. Tesamorelin: a growth hormone-releasing factor analogue for HIV-associated lipodystrophy. Ann Pharmacother 2012; 46: 240-7. (Review of the safety and efficacy of tesamorelin in HIV infected patients with lipodystrophy; mentions that headache and arthralgias were the most frequent adverse events that led to discontinuation; no mention of ALT elevations or hepatotoxicity). 22298602
Stanley TL, Feldpausch MN, Oh J, Branch KL, Lee H, Torriani M, Grinspoon SK. Effect of tesamorelin on visceral fat and liver fat in HIV-infected patients with abdominal fat accumulation: a randomized clinical trial. JAMA 2014; 312: 380-9. (Among 48 HIV infected patients with excess visceral and hepatic fat treated with tesamorelin vs placebo for 6 months, median changes in hepatic fat were -2% vs +1%, while median ALT levels did not change in either group [20 to 20 U/L vs 19 to 17 U/L]). 25038357
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to tesamorelin). 25754159
Fourman LT, Czerwonka N, Feldpausch MN, Weiss J, Mamputu JC, Falutz J, Morin J, et al. Visceral fat reduction with tesamorelin is associated with improved liver enzymes in HIV. AIDS 2017; 31: 2253-9. (Among 176 patients with HIV infection and ALT or AST elevations who were treated with tesamorelin for reduction of visceral adipose tissue [VAT], mean aminotransferase levels decreased more in those with a decrease in VAT [ALT by -9 vs +1 U/L and AST by -4 vs 0 U/L]).
Clemmons DR, Miller S, Mamputu JC. Safety and metabolic effects of tesamorelin, a growth hormone-releasing factor analogue, in patients with type 2 diabetes: A randomized, placebo-controlled trial. PLoS One 2017; 12: e0179538. (Among 53 patients with type 2 diabetes treated with tesamorelin or placebo for 12 weeks, there were no changes in measures of insulin response or diabetes control (fasting glucose or HbA1c levels); no mention of ALT levels or liver related adverse events). 28617838

## OTHER REFERENCE LINKS

1. Recent References on Tesamorelin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tesamorelin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tesamorelin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tesamorelin)